# Nonalcoholic Fatty Liver

Description. Nonalcoholic fatty liver disease (NAFLD) and steatohepatitis are well documented but rare forms of drug induced liver injury. In addition, fatty liver disease is more often chronic than acute even when drug induced. Drug induced fatty liver is characterized by mild to moderate serum enzyme elevations, generally with a hepatocellular pattern arising in a patient with fatty liver, as shown by liver biopsy or imaging tests, usually ultrasound. The clinical presentation resembles nonalcoholic fatty liver disease and may sometimes merely represent exacerbation of an underlying NAFLD caused by the medication or weight gain triggered by the medication.

Latency to Onset. The time to onset of NAFLD is typically 3 to 12 months, but may occur up years after starting medication.

Symptoms. Symptoms are usually absent or mild and nonspecific. The diagnosis is usually made based upon laboratory or imaging test results done routinely or for an independent reason. Dark urine, jaundice, and pruritus are uncommon and immunoallergic features are rarely present.

Serum Enzyme Elevations. Serum enzymes are usually only mildly elevated, typically in a hepatocellular pattern, more suggestive of chronic rather than acute hepatitis. Serum bilirubin is rarely elevated and the INR is preserved unless cirrhosis is present.

Drugs. Medications commonly implicated in causing fatty liver include corticosteroids, antidepressant and antipsychotic medications and, most commonly, tamoxifen. In many instances, it is unclear whether the fatty liver disease is a direct result of the medication on the liver or a consequence of weight gain triggered by the medication (as occurs with many antidepressant or antipsychotic medications). Amiodarone and methotrexate are also capable of causing fatty liver disease and hepatic injury that resembles alcoholic hepatitis with fat, lobular disarray, inflammation, Mallory bodies and fibrosis. With these two agents, however, the inflammation and fibrosis generally overshadows the degree of steatosis. Both of these agents can cause fibrosis and cirrhosis.

Differential Diagnosis. The finding of serum enzyme elevations with fat on liver biopsy or imaging suggests nonalcoholic fatty liver, and the role of medications should be suspect if an agent associated with fatty liver is being taken.

Definition. The diagnosis of NAFLD requires the finding of serum enzyme elevations and fat in the liver as shown by imaging tests or liver biopsy:

1 Hepatocellular pattern of serum enzyme elevations (R value >5) with minimal alkaline phosphatase elevations
2 Latency of 3 to 12 months after starting the medication
3 Nonspecific symptoms (if present) of nausea, fatigue, or abdominal pain
4 Fat in the liver as shown by ultrasound, computerized tomography or magnetic resonance imaging
5 If liver biopsy is obtained, changes of steatosis, inflammation and ballooning degeneration
6 Resolution or lessening of evidence of liver injury and fatty liver with stopping the medication.

Because nonalcoholic fatty liver is so frequent in the general population, the finding of serum enzyme elevations and fat in the liver by imaging tests is not uncommon, particularly in patients who are overweight or have hyperlipidemia or diabetes - patients who are also likely to be taking medications. Thus, the diagnosis of drug induced NAFLD is challenging, and should rest upon the de novo appearance of liver enzyme elevations or hepatic fat in a patient known to be free of these findings before starting the drug; or, alternatively, the resolution of these findings with stopping the medication. Some cases of drug induced NAFLD actually represent an underlying propensity to this metabolic liver disease in a patient on a medication that causes weight gain or disturbances in lipid or glucose metabolism. The most clearly defined cause of drug induced NAFLD is tamoxifen which is typically given long term (up to five years) in postmenopausal women, many of whom may already have risk factors for NAFLD, such as obesity, diabetes or hyperlipidemia. The presence of steatosis and ballooning degeneration, inflammation and variable degrees of fibrosis is generally referred to as nonaclcoholic steatohepatitis (NASH) and is considered a more severe part of the spectrum of NAFLD, being potentially progressive and leading to advanced fibrosis or cirrhosis. Amiodarone and methotrexate are two other agents that can cause NAFLD and NASH and often present at a more advanced stage accompanied by inflammation and fibrosis.

## Representative Cases

### Case 1. Nonalcoholic steatohepatitis induced by tamoxifen.

[DILIN Case #105-3016]

A 37 year old woman was found to have abnormal serum enzymes during long term tamoxifen therapy. Two years previously, she had been found to have bilateral breast cancers and underwent bilateral mastectomies followed by reconstructive breast surgery. The breast cancer tissue was human estrogen receptor negative. She was started on long term tamoxifen (20 mg daily) and goserelin (3.6 mg implant monthly) therapy. Before starting therapy, her serum enzymes were normal (Table), but one year later they were found to be elevated. She had no symptoms of liver disease and specifically denied fatigue, nausea and abdominal pain. She had no history of liver disease and denied alcohol use. She had no risk factors for viral hepatitis and was not taking other medications. Physical examination showed no fever, rash, abdominal tenderness or enlargement of liver or spleen. She was mildly overweight (body mass index 28.5), but had not gained weight in the previous year. Laboratory results showed moderate elevations in serum aminotransferase levels (ALT 150 U/L, AST 138 U/L), with normal alkaline phosphatase, bilirubin (0.3 mg/dL), albumin (4.5 g/dL) and prothrombin time (INR 1.1). Fasting blood glucose and lipids were normal. Tests for hepatitis A, B and C were negative as were autoantibodies. Serum ceruloplasmin was normal (34.4 mg/dL). Ultrasound of the abdomen suggested fatty liver. A liver biopsy showed severe macrovesicular steatosis with lobular hepatitis, and mild pericellular fibrosis without Mallory bodies, compatible with steatohepatitis. The combination of ursodeoxycholic acid, vitamin C and vitamin E were started and tamoxifen continued. Serum enzymes remained elevated and six months later began to rise reaching a peak of an ALT 770 U/L, AST 810 U/L, despite minimal or no rise in alkaline phosphatase and bilirubin levels. At this point, the patient began to complain of fatigue, nausea, vague abdominal discomfort, dark urine and itching. Tamoxifen and goserelin were discontinued. A repeat liver biopsy showed less steatosis, but increased lobular inflammation, ballooning degeneration and fibrosis with multiple Mallory bodies. Over the next several months, serum aminotransferases decreased minimally.

#### Key Points

Medication: | Tamoxifen (20 mg daily)
Pattern: | Hepatocellular (R=15)
Severity: | 1+ (serum enzyme elevations only with symptoms)
Latency: | 2 years
Recovery: | Incomplete after 2 months
Other medications: | Goserelin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 24 | 55 | 0.7 | 1 month before surgery
18 months | | 150 | 65 | 0.2
20 months | | 189 | 75 | 0.3 | Liver biopsy
21 months | | 143 | 67 | 0.3 | Vitamin E and ursodiol
23 months | | 149 | 65 | 0.3
26 months | | 292 | 64 | 0.4
29 months | 0 | 770 | 112 | 0.5 | Tamoxifen stopped
30 months | 1 month | 567 | 103 | 0.5 | Liver biopsy
31 months | 2 months | 418 | 102 | 0.4
Normal Values | | <40 | <104 | <1.2

#### Comment

Fatty liver develops in up to one third of women treated with tamoxifen, but is usually benign and not associated with serum enzyme elevations, symptoms or progressive liver disease. In a proportion of patients, however, the accumulation of fat is associated with appearance of inflammation and cell injury (steatohepatitis), which can lead to progressive fibrosis and ultimately to cirrhosis. Serum aminotransferase levels are usually minimally elevated. In this case, ALT elevations were moderate and persistent, leading to liver biopsy and attempts to treat the fatty liver injury using ursodiol and vitamin E while continuing tamoxifen. These interventions appeared to have no effect, and serum enzymes continued to rise. A follow up liver biopsy showed worsening of the injury and progressive fibrosis. Stopping tamoxifen led to improvements in serum enzyme elevations but the improvement was slow and incomplete.

### Case 2. Nonalcoholic steatohepatitis after long term corticosteroid therapy.

[Modified from: Itoh S, Igarashi M, Tsukada Y, Ichinoe A. Nonalcoholic fatty liver with alcoholic hyaline after long-term glucocorticoid therapy. Acta Hepato-Gastroenterologica 1977; 24: 415-8. PubMed Citation]

A 34 year old woman with systemic lupus erythematosis was treated with betamethasone with good clinical response with improvements in rash, fatigue and laboratory tests. Over a 6 month period, the daily dosage was gradually decreased from 5 to 1.25 mg daily. Initially, her liver tests were normal, but with corticosteroid therapy, ALT and AST were mildly elevated (Table). However, after 16 months of therapy, serum aminotransferase levels were more than 5 fold elevated (ALT 256 U/L, AST 272 U/L) and she was readmitted for evaluation. Her weight had risen by 11 kilograms and she had firm hepatomegaly. Laboratory tests showed elevations in serum aminotransferase levels, but normal serum bilirubin, albumin, and prothrombin time. She had an abnormal glucose tolerance test (fasting 118 mg/dL, 2 hour postprandial glucose 248 mg/dL). Testing for HBsAg was negative. She was known to be positive for antinuclear antibody (1:128). She denied alcohol use which was confirmed by family and friends. A liver biopsy showed marked steatosis with inflammation including neutrophils, occasional Mallory bodies and mild central sinusoidal and portal fibrosis. Weight loss led to slight decreases in serum ALT levels.

#### Key Points

Medication: | Betamethasone (1.25 mg daily)
Pattern: | Hepatocellular or mixed (R=~4.6)
Severity: | Mild (serum enzyme elevations only)
Latency: | Several months
Recovery: | Not mentioned
Other medications: | None mentioned

#### Laboratory Values

Months After Starting | Body Weight (kg) | ALT (U/L) | Alk P (U/L) | Albumin (g/dL) | Other
0 | 42.7 | 18 | 95 | 3.4
6 | 52.2 | 58 | 62 | 3.9
16 | 58.2 | 256 | 131 | 4.0 | Protime 10.4 sec
17 | 55.5 | 134 | 76 | 4.2
Normal Values | | <40 | <85 | <3.5

#### Comment

This is an early but well documented report of nonalcoholic steatohepatitis arising during corticosteroid therapy. The patient was evidently asymptomatic of liver disease, but the height of the serum aminotransferase elevations led to a hospital admission and liver biopsy. An issue is whether the liver disease was due to corticosteroid therapy directly or was the result of weight gain and insulin resistance caused by the therapy, the latter being more likely. Betamethasone is a synthetic, high potency glucocorticoid; 1.25 mg of betamethasone is roughly equivalent to 15 mg of prednisone.

## Hepatic Histology of Drug Induced Fatty Liver Disease

[Under Construction